# Antithymocyte Globulin

## OVERVIEW

### Introduction

Antithymocyte globulin (ATG) is an antibody preparation derived from rabbits or horses hyperimmunized with human thymocytes, which is used to prevent or treat acute cellular rejection after solid organ transplantation and as a therapy of acute aplastic anemia. ATG has been linked to acute elevations in serum enzyme elevations shortly following infusions, but has not been linked to cases of clinically apparent liver injury. ATG is a potent immunosuppressive agent and may result in reactivation of hepatitis B in susceptible patients.

### Background

Antithymocyte globulin is a hyperimmune globulin preparation made from plasma of rabbits or horses that have been immunized with human thymocytes or T cells. ATG is given by infusion only and leads to a rapid decrease in circulating T cells. ATG has been shown to be effective in preventing and treating acute cellular rejection after renal transplantation, and has been used extensively for the same indications after heart and liver transplantation. The antibodies are polyclonal and are directed at multiple T cell markers (such as CD2, CD3, CD4, CD8, CD 11) as well as HLA markers, beta-2-microglobulin and other tissue antigens (including cytoplasmic and nuclear liver antigens). Equine ATG is also used to treat severe aplastic anemia. ATG was initially approved for use in the United States as treatment of acute cellular rejection after renal transplantation. Since then, the indications for its use have been broadened, although there remains considerable off label use as well. Two commercial products are available in the United States: Thymoglobulin (rabbit ATG) and Atgam (horse ATG). Dose regimens vary by product and clinical indications. The usual regimen for treating acute rejection in adults is a 7 to 14 day course of daily infusion of 1.5 mg/kg of Thymoglobulin or 15 mg/kg of Atgam. ATG is typically used in combination with other immunosuppressive agents and should be prescribed only by physicians experienced in management of immunosuppression. Adverse events are common during ATG administration, but many are due to the underlying condition and other complications of organ transplantation or aplastic anemia. Because ATG is made from animal serum, it can induce serious immune mediated reactions such as acute infusion reactions, anaphylaxis, serum sickness and cytokine release syndrome. ATG is a foreign protein (xenotypic) and may induce inactivating antibodies with repeated use. Furthermore, the initial engagement of T cells by the antibody can result in a transient, acute release of proinflammatory cytokines (cytokine release syndrome) with symptoms of high fever, weakness, dyspnea, nausea, chest pain and diarrhea arising within the first two days of starting therapy. Less common, but potentially severe adverse reactions reported to occur after ATG therapy include bacterial and opportunistic infections, reactivation of viral infections (EBV, HSV, CMV, HBV, RSV, among others), acute thromboses, and malignancies, particularly EBV-associated lymphoproliferative disorders.

### Hepatotoxicity

When given as a part of induction therapy for solid organ transplantation, ATG has not been linked to serum enzyme elevations or hepatotoxicity, but it is given with other medications and in preparation for major surgery so that some degree of liver injury might well be missed. In patients with aplastic anemia given ATG, transient serum enzyme elevations arising a few days after the infusions have been reported to occur in up to one-third of patients. These abnormalities generally resolve spontaneously without jaundice or symptoms. Serum alkaline phosphatase and bilirubin levels rise minimally, if at all. There have been no convincing cases of acute, clinically apparent liver injury caused by ATG infusions. Indeed, administration of ATG for acute rejection after liver transplantation is usually followed by a prompt decrease in serum enzymes and jaundice, and administration of ATG for aplastic anemia with hepatitis or hepatitis from check point inhibitors such as ipilumumab commonly results in a prompt improvement in the jaundice and serum enzyme elevations. ATG has occasionally been implicated in causing a worsening of chronic hepatitis C after transplantation, but is not generally implicated as a major cause of long term severe outcomes of recurrent hepatitis C infection.

Likelihood score: E* (unproven, but suspected cause of anicteric liver injury).

ATG is a potent immunosuppressive agent and may be capable of causing reactivation of chronic hepatitis B. However, when used in prevention of organ rejection it has not been linked to cases of reactivation, perhaps because patients at risk are routinely given prophylaxis and the role of ATG versus other rejection medications (cyclosporine, tacrolimus, corticosteroids) is not clear.

### Mechanism of Injury

The cause of serum enzyme elevations after ATG use is not known, but may relate to cytotoxicity of the polyclonal antibodies to liver cells or to the known propensity of injured, apoptotic T lymphocytes to home to the liver. Liver injury generally arises after ATG infusions have stopped or between courses of treatment.

### Outcome and Management

The liver injury associated with ATG therapy is generally mild and self-limited without symptoms or jaundice. The other forms of hypersensitivity reactions to ATG are usually more likely to call for alteration in administration or avoidance of further infusions.

Monoclonal agents used in the treatment or prevention of transplant rejection include alemtuzumab, basiliximab, daclizumab, and muromonab.

Drug Class: Transplant Agents, Polyclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Antithymocyte Globulin [Equine] – Atgam®

Antithymocyte Globulin [Rabbit] – Thymoglobulin®

DRUG CLASS

Transplant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Antithymocyte)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Antithymocyte [Antilymphocyte] Globulin | 308067-60-9 | Polyclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 25 July 2017

Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents mentions ATG and problems of reactivation of hepatitis).
Krensky AM, Bennett WM, Vincenti F. Immunosuppressants, tolerogens, and immunostimulants. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1005-1029. (Textbook of pharmacology and therapeutics).
Starzl TE, Marchioro TL, Hutchinson DE, Porter KA, Cerilli GJ, Brettschneider L. The clinical use of antilymphocyte globulin in renal homotransplantation. Transplantation 1967; 5: Suppl: 1100-5. (Among 20 renal transplant recipients treated with antilymphocyte globulin [horse], 19 survived and had good renal function after 1-7 months; no mention of ALT elevations or hepatotoxicity). 4167452
Najarian JS, Simmons RL. The clinical use of antilymphocyte globulin. N Engl J Med 1971; 285: 158-66. (Review of the history of development, mechanism of action, efficacy and side effects of antilymphocyte globulin; no mention of ALT elevations or hepatotoxicity). 4103453
Doney KC, Weiden PL, Buckner CD, Storb R, Thomas ED. Treatment of severe aplastic anemia using antithymocyte globulin with or without an infusion of HLA haploidentical marrow. Exp Hematol 1981; 9: 829-34. (Among 19 patients with aplastic anemia treated with ATG with or without marrow infusions, survival was 42% and side effects included fever and chills in all, rash in 84%, liver enzyme elevations in 37% with serum sickness symptoms responding to corticosteroid therapy). 7035206
Harada M, Gale RP. Evaluation of antithymocyte globulin for human bone marrow transplantation. Antihematopoietic and immunosuppressive activity. Transplantation 1982; 33: 625-30. (Absorption of ATG using fetal liver cells was effective in removing cytotoxicity to hematopoietic stem cells, but did not affect the immunosuppressive activity [which is directed primarily against mature T cells] of the antibody preparation). 7048664
Champlin R, Ho W, Gale RP. Antithymocyte globulin treatment in patients with aplastic anemia: a prospective randomized trial. N Engl J Med 1983; 308: 113-8. (Controlled trial in 42 patients with severe aplastic anemia found response rate of 52% with ATG vs 0% with placebo; all ATG recipients had symptoms of serum sickness responding to corticosteroids; no mention of ALT elevations or hepatotoxicity). 6336819
Greco B, Bielory L, Stephany D, Hsu SM, Gascon P, Nienhuis A, Young N. Antithymocyte globulin reacts with many normal human cell types. Blood 1983; 62:1047-54. (ATG has antibody reactivity not just to T cells, but also to granulocytes, bone marrow cells, and yields nuclear and cytoplasmic staining of many tissues including hepatocytes). 6354303
Doney K, Storb R, Buckner CD, McGuffin R, Witherspoon R, Deeg HJ, Appelbaum FR, et al. Treatment of aplastic anemia with antithymocyte globulin, high-dose corticosteroids, and androgens. Exp Hematol 1987; 15: 239-42. (Among 46 patients with aplastic anemia treated with ATG, corticosteroids and androgens, long term survival was 74%; side effects included serum sickness in 23 [50%] and ALT elevations in 12 [26%], which led to discontinuation of androgens in 8 [17%]). 3493172
Means RT Jr, Krantz SB, Dessypris EN, Lukens JN, Niblack GD, Greer JP, Flexner JM, et al. Re-treatment of aplastic anemia with antithymocyte globulin or antilymphocyte serum. Am J Med 1988; 84: 678-82. (Among 22 patients with aplastic anemia treated with ALS or ATG, 32% responded to the initial course and 44% [4 of 9] to retreatment; no mention of side effects). 3261125
Claesson K, Tufveson G, Wahlberg J. Treatment with poly- and monoclonal antilymphocyte antibodies: assessment of efficacy and safety in transplantation. Transplant Proc 1992; 24: 314. (Among 145 patients undergoing organ transplantation, graft survival and adverse events were similar in those who received antibody therapy of rejection and those who did not; no mention of ALT elevations or hepatotoxicity). 1539293
Toren A, Ilan Y, Or R, Kapelushnik J, Nagler A. Impaired liver function tests in patients treated with antithymocyte globulin: implication for liver transplantation. Med Oncol 1997; 14: 125-9. (Among 16 patients receiving ATG in preparation of hematopoietic cell transplantation, serum ALT, AST, GGT and LDH levels increased by 1 to 5 fold [ALT rising from 52 to 185 U/L by day 3 and bilirubin from 1.1 to 1.9 mg/dL], but not in 5 patients with aplastic anemia treated with ATG). 9468033
Killick SB, Marsh JC, Booth JC, Gordon-Smith EC. Liver function abnormality following treatment with antithymocyte globulin for aplastic anaemia. Bone Marrow Transplant 1997; 19: 249-51. (Among 18 patients with aplastic anemia treated with ATG [horse and rabbit] in 1-3 courses of 5 daily injections, 15 had a transient rise in ALT [peak 49-741 U/L] with no change in bilirubin or Alk P, usually rising within 4 days after the infusions and persisting for several weeks, but in 2 patients for more than 30 days). 9028554
Brown KE, Tisdale J, Barrett AJ, Dunbar CE, Young NS. Hepatitis-associated aplastic anemia. N Engl J Med 1997; 336: 1059-64. (Among 10 patients with severe aplastic anemia arising 1-7 weeks after onset of acute seronegative hepatitis who were treated with horse ATG [4 days] and cyclosporine [6 months], the long term response rate was 70%, and ALT levels fell in all 10 patients, becoming normal within 30 days in 9). 9091802
Marsh J, Schrezenmeier H, Marin P, Ilhan O, Ljungman P, McCann S, Socie G, et al. Prospective randomized multicenter study comparing cyclosporin alone versus the combination of antithymocyte globulin and cyclosporin for treatment of patients with nonsevere aplastic anemia: a report from the European Blood and Marrow Transplant (EBMT) Severe Aplastic Anaemia Working Party. Blood 1999; 93: 2191-5. (Among 115 patients with aplastic anemia treated with cyclosporine alone or in combination with ATG [horse], overall response rates were higher with the combination; no discussion of side effects). 10090926
Frickhofen N, Rosenfeld SJ. Immunosuppressive treatment of aplastic anemia with antithymocyte globulin and cyclosporine. Semin Hematol 2000; 37: 56-68. (Review of the therapy of aplastic anemia focusing upon ATG and cyclosporine). 10676911
Midtvedt K, Fauchald P, Lien B, Hartmann A, Albrechtsen D, Bjerkely BL, Leivestad T, et al. Individualized T cell monitored administration of ATG versus OKT3 in steroid-resistant kidney graft rejection. Clin Transplant 2003; 17: 69-74. (Among 55 patients undergoing renal transplantation treated with variable doses of either ATG or muromonab based upon T cell counts, rejection rates were similar as were adverse events; no mention of ALT elevations or hepatotoxicity). 12588325
Champlin RE, Perez WS, Passweg JR, Klein JP, Camitta BM, Gluckman E, Bredeson CN, et al. Bone marrow transplantation for severe aplastic anemia: a randomized controlled study of conditioning regimens. Blood 2007; 109: 4582-5. (Among 134 patients undergoing hematopoietic cell transplantation for aplastic anemia treated with cyclophosphamide alone or in combination with ATG, rates of bone marrow recovery and graft-vs-host disease were similar in the two groups, as were side effects of infection; no mention of ALT elevations or hepatotoxicity). 17272503
Lundquist AL, Chari RS, Wood JH, Miller GG, Schaefer HM, Raiford DS, Wright KJ, et al. Serum sickness following rabbit antithymocyte-globulin induction in a liver transplant recipient: case report and literature review. Liver Transpl 2007; 13: 647-50. (45 year old woman received ATG for 4 days at the time of liver transplantation for hepatitis C and developed fever 9 days after transplant, followed by arthralgias diagnosed as serum sickness; no mention of liver tests). 17377915
Boillot O, Seket B, Dumortier J, Pittau G, Boucaud C, Bouffard Y, Scoazec JY. Thymoglobulin induction in liver transplant recipients with a tacrolimus, mycophenolate mofetil, and steroid immunosuppressive regimen: a five-year randomized prospective study. Liver Transpl 2009; 15: 1426-34. (Among 93 patients undergoing liver transplantation with or without ATG induction, rates of acute rejection, graft and patient survival were similar; no mention of hepatotoxicity). 19877264
Atta EH, Dias DS, Marra VL, de Azevedo AM. Comparison between horse and rabbit antithymocyte globulin as first-line treatment for patients with severe aplastic anemia: a single-center retrospective study. Ann Hematol 2010; 89: 851-9. (Retrospective analysis of ATG treatment of 71 patients with aplastic anemia, found 6 month response rates higher with horse [60%] compared to rabbit [35%] ATG; no mention of ALT elevations or hepatotoxicity). 20373101
Schmitt TM, Phillips M, Sawyer RG, Northup P, Hagspiel KD, Pruett TL, Bonatti HJ. Anti-thymocyte globulin for the treatment of acute cellular rejection following liver transplantation. Dig Dis Sci 2010; 55: 3224-34. (Results of treating 20 patients with ATG for acute rejection after liver transplantation; all responded with improvements in ALT and AST, but those with hepatitis C had recurrence of injury and one patient died after a marked ALT elevation following therapy). 20238251
Cai J, Terasaki PI. Induction immunosuppression improves long-term graft and patient outcome in organ transplantation: an analysis of United Network for Organ Sharing registry data. Transplantation 2010; 90: 1511-5. (Since 2003, most solid organ transplant recipients have received induction therapy, and analyses of the UNOS registry for this period shows highest rates of patient and graft survival with alemtuzumab [89% 5 year patient survival] as compared to ATG [89%], basiliximab [84%], daclizumab [77%], steroids [75%] or no induction [71%]). 21057388
Marks WH, Ilsley JN, Dharnidharka VR. Posttransplantation lymphoproliferative disorder in kidney and heart transplant recipients receiving thymoglobulin: a systematic review. Transplant Proc 2011; 43: 1395-404. (Systematic review of PTLD after induction therapy with ATG before transplantation found overall rate of 1% with higher rates in patients not given prophylaxis with antiviral agents). 21693205
Scheinberg P, Nunez O, Weinstein B, Scheinberg P, Biancotto A, Wu CO, Young NS. Horse versus rabbit antithymocyte globulin in acquired aplastic anemia. N Engl J Med 2011; 365: 430-8. (Controlled trial of different ATG products in 120 patients with severe aplastic anemia found higher rates of response to the horse vs rabbit ATG [68% vs 37% at 6 months], but similar profile of side effects, the major serious side effects being infection; no mention of ALT elevations or hepatotoxicity). 21812672
Ahmed T, Pandey R, Shah B, Black J. Resolution of ipilimumab induced severe hepatotoxicity with triple immunosuppressants therapy. BMJ Case Rep 2015; 1-4. (50 year old woman with melanoma developed fatigue and fever during ipilumumab therapy of melanoma [bilirubin 0.9 mg/Dl, ALT 640 U/L, Alk P 366 U/L], resolving within 30 days of starting methylprednisone and horse ATG). 26174726
Chmiel KD, Suan D, Liddle C, Nankivell B, Ibrahim R, Bautista C, Thompson J, et al. Resolution of severe ipilimumab-induced hepatitis after antithymocyte globulin therapy. J Clin Oncol 2011; 29: e237-40. (60 year old man with melanoma developed anorexia, rash and fever 10 days after a second infusion of ipilimumab [peak bilirubin 1.2 mg/dL, ALT 2521 U/L, Alk P 275 U/L] treated with methyl prednisolone and relapsed when it was tapered [bilirubin 3.9 mg/dL, ALT 6362 U/L, Alk P 147 U/L, INR 1.4], with rapid recovery [2-3 weeks] upon increasing corticosteroids and administering 4 infusions of rabbit ATG). 21220617
Chang A, Lee-Lam FY, Wang J, Cheng YH. Transient liver function abnormality following treatment with rabbit antithymocyte globulin for nonmyeloablative hematopoetic stem cell transplant: two case reports. J Oncol Pharm Pract 2015; 21: 67-71. (Two patients, 66 and 72 year old women with leukemia and lymphoma developed ALT elevations [peak 702 and 689 U/L] within a few hours of finishing 5-day infusions of rabbit ATG which resolved within one week; patients also received acetaminophen and methyl prednisolone). 24395543
Scheinberg P, Nunez O, Weinstein B, Scheinberg P, Wu CO, Young NS. Activity of alemtuzumab monotherapy in treatment-naive, relapsed, and refractory severe acquired aplastic anemia. Blood 2012; 119: 345-54. (In three prospective studies evaluating alemtuzumab [monoclonal anti-CD52] in a total of 90 patients, response rates were lower than with ATG in treatment-naïve patients, but alemtuzumab may have a role in ATG refractory and relapsed patients; no mention of ALT elevations or hepatotoxicity in summary of adverse reactions). 22067384
Mangus RS, Fridell JA, Vianna RM, Kwo PY, Chen J, Tector AJ. Immunosuppression induction with rabbit anti-thymocyte globulin with or without rituximab in 1000 liver transplant patients with long-term follow-up. Liver Transpl 2012; 18: 786-95. (Description of results using ATG induction in 1013 patients underlying liver transplantation at a single referral center; no mention of hepatotoxicity or ALT elevations). 22237953
Berenguer M, Pons JA. Rabbit anti-thymocyte globulin in liver transplantation: all that glitters is not gold, but 1000 patients are so many to dazzle. Liver Transpl 2012; 18: 755-60. (Editorial in response to Magnus [2012] decrying the lack of prospectively controlled trials of induction regimens before transplantation). 22431230
Kadia TM, Borthakur G, Garcia-Manero G, Faderl S, Jabbour E, Estrov Z, York S, et al. Final results of the phase II study of rabbit anti-thymocyte globulin, ciclosporin, methylprednisone, and granulocyte colony-stimulating factor in patients with aplastic anaemia and myelodysplastic syndrome. Br J Haematol 2012; 157: 312-20. (Open label trial of ATG [rabbit] with cyclosporine, corticosteroids and GCSF in 24 patients with aplastic anemia and 24 with myelodysplasia reported common side effects were neutropenia [50%], infusion reactions [27%], serious infections [27%], increased ALT levels [33%], and elevations in bilirubin levels [31%]). 22360602
Taylor S, Hu C, Pan DH, Manwani D. Treatment of acquired aplastic anemia in patients with acute liver failure occurring concurrently: a case series. J Pediatr Hematol Oncol 2012; 34: e349-52. (Two patients with aplastic anemia and severe hepatitis were treated with ATG, corticosteroids and cyclosporine [amounts and regimens not given], both patients recovering and liver injury resolving despite the immunosuppressive therapy). 23018574
Ecsedi M, Schmohl J, Zeiser R, Drexler B, Halter J, Medinger M, Duyster J, et al. Anti-thymocyte globulin-induced hyperbilirubinemia in patients with myelofibrosis undergoing allogeneic hematopoietic cell transplantation. Ann Hematol 2016; 95: 1627-36. (Retrospective analysis of 94 patients with myelofibrosis (MF) and 158 with other conditions undergoing hematopoietic cell transplantation with conditioning regimens including ATG, found that 90% of MF vs 54% of others developed bilirubin elevations after ATG infusions, rising from 0.6-1.5 to 1.0-4.6 mg/dL and rapidly returning to baseline, inconsistently associated with serum enzyme; no mention of direct bilirubin or bile acid levels). 27480090
Lee JG, Lee J, Lee JJ, Song SH, Ju MK, Choi GH, Kim MS, et al. Efficacy of rabbit anti-thymocyte globulin for steroid-resistant acute rejection after liver transplantation. Medicine (Baltimore) 2016; 95: e3711. (Retrospective analysis of 11 cases of steroid-resistant acute cellular rejection treated with rabbit ATG for 6-10 days found that all responded with prompt decline in bilirubin [mean 6.5 to 4.8 mg/dL], ALT [327 to 70 U/L] and Alk P [359 to 299 U/L], and most had normal values by 2 weeks). 27281070
Petite SE, Bollinger JE, Eghtesad B. Antithymocyte globulin induction therapy in liver transplant: old drug, new uses. Ann Pharmacother 2016; 50: 592-8. (Review of the use of rabbit ATG in induction regimens for liver transplantation; no mention of hepatotoxicity). 27147705

## OTHER REFERENCE LINKS

1. Recent References on Antithymocyte Globulin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Antithymocyte+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Antithymocyte Globulin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Antithymocyte)